# Alpelisib

## OVERVIEW

### Introduction

Alpelisib is an oral selective inhibitor of the phosphoinositol-3-kinase (PIK3) which is mutated in several forms of solid tumors and is approved for use in specific forms of advanced or metastatic breast cancer. Serum aminotransferase elevations are common during alpelisib therapy but clinically apparent liver injury with jaundice has not been reported with its use and must be rare, if it occurs at all.

### Background

Alpelisib (al” pe lis’ ib) is an orally available, small molecule inhibitor of the alpha catalytic subunit of phosphoinositol-3 kinase (PIK3CA), an important mediator of cell growth and proliferation. Mutations in PIK3CA are found in several forms of cancer, including breast, ovarian and colorectal carcinoma. These mutations result in dysregulation of cell growth, differentiation, proliferation and apoptosis, pathways that are important in the development of cancer. Specific mutations in PIK3CA are found most frequently (~40%) in hormone receptor positive (HR+), human epidermal growth factor 2 negative (HER2-) breast cancer. Clinical trials of alpelisib combined with antiestrogens in postmenopausal women with breast cancer demonstrate prolongation of both overall and progression free survival. The increase in overall response rates were found only in patients with PIK3CA mutant forms of cancer, and not in unmutated, wild type forms of PIK3CA. Alpelisib was approved in the United States as therapy in combination with fulvestrant for postmenopausal women or men with advanced or metastatic HR+, HER2- breast cancer with mutated PIK3CA. Alpelisib is available in tablets of 50, 150 and 200 mg under the brand name Piqray. The recommended dose is 300 mg once daily. Dose reductions to 250 and 200 mg daily are often needed, but lower doses are not recommended. Alpelisib is given in combination with fulvestrant, an anti-estrogen, the recommended dosage being 500 mg given intramuscularly on days 1, 15 and 29 and monthly thereafter. Side effects of combination alpelisib-fulvestrant therapy are common and arise in almost all patients and can include hyperglycemia, diarrhea, nausea and vomiting, decreased appetite, fatigue, rash, stomatitis, weight loss, and elevations in serum creatinine, lipase and aminotransferase levels. Uncommon but potentially severe adverse events include hypersensitivity reactions, severe cutaneous reactions including DRESS and Stevens Johnson syndrome, pneumonitis and interstitial lung disease, severe diarrhea with dehydration, marked hyperglycemia, and embryo-fetal toxicity.

### Hepatotoxicity

In the prelicensure clinical trials of alpelisib in patients with cancer, liver test abnormalities were frequent although usually transient, asymptomatic, and mild-to-moderate in severity. Some degree of ALT elevation arose in up to 44% of alpelisib- and fulvestrant-treated patients, but were above 5 times the upper limit of normal (ULN) in only 3% to 4%. The aminotransferase elevations rarely necessitated dose modifications or interruptions, and only slightly lower rates of enzyme elevations occurred in patients taking fulvestrant without alpelisib. In these trials that enrolled less than 1000 patients, there were several reports of marked serum aminotransferase elevations that led to early discontinuation. However, the nature and clinical features of the liver injury were not provided and there were no cases of clinically apparent liver injury. Skin rashes were also common with alpelisib therapy, and patients are often given prophylactic antihistamines which appear to result in fewer and milder rashes. However, moderate-to-severe rash can occur and some are accompanied by drug reaction with eosinophilia and systemic signs (DRESS) syndrome, some degree of liver injury (usually anicteric and asymptomatic) being a part of the manifestations.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of liver injury from alpelisib is unknown, but with pattern of abnormalities suggests some degree of low level, direct hepatotoxicity. Alpelisib is metabolized in the liver via the cytochrome P450 system, largely CYP 3A4 and 2C9, and is susceptible to drug-drug interactions with agents that inhibit or induce the CYP enzyme reactivity.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Outcome and Management

Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to dose reduction or temporary interruption of alpelisib therapy. In patients with clinically apparent liver injury and jaundice, restarting therapy should be done with caution but with aminotransferase elevations without jaundice or symptoms, cautious reintroduction of therapy can be attempted. Cross sensitivity to liver injury is uncommon among the tyrosine kinase inhibitors but there is no information or shared adverse event sensitivity of alpelisib with other antineoplastic protein kinase inhibitors.

Drug Class: Antineoplastic Agents, Tyrosine Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Alpelisib – Piqray®

DRUG CLASS

Antineoplastic Agents, Kinase Inhibitors

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Alpelisib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Alpelisib | 1217486-61-7 | C19-H22-F3-N5-O2-S

## ANNOTATED BIBLIOGRAPHY

References updated: 15 September 2021

Abbreviations: PIK3CA, phosphidylinositol-3 kinase alpha catalytic subunit; ER+, estrogen receptor positive; HER2-, human epidermal growth factor receptor 2 negative; HR+, hormone receptor positive; PR+, progesterone receptor positive.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors).
DeLeve LD. Kinase inhibitors. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents, does not discuss alpelisib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/212526Orig1s000MultidisciplineR.pdf (FDA website with product labels and initial clinical review of the safety and efficacy of alpelisib; states that virtually all patients treated with alpelisib with fulvestrant developed at least one adverse event and dose modifications were frequent, but ALT and AST elevations were usually mild-to-moderate, transient and asymptomatic, rising to above normal in 44% [vs 34% of controls] and above 5 times ULN in only 3% [vs 2% of controls] and no patient developed clinically apparent liver injury with jaundice).
Rodon J, Curigliano G, Delord JP, Harb W, Azaro A, Han Y, Wilke C, et al. (2018). A Phase Ib, open-label, dose-finding study of alpelisib in combination with paclitaxel in patients with advanced solid tumors. Oncotarget. (Among 19 adults with various advanced solid tumors treated with escalating doses of alpelisib [150, 250, and 300 mg daily] with fixed doses of paclitaxel, dose-limiting toxicities were common [hyperglycemia, renal dysfunction, leukopenia] even at the lower doses, and the study was terminated early; no mention of ALT elevations or hepatotoxicity).
Jain S, Shah AN, Santa-Maria CA, Siziopikou K, Rademaker A, Helenowski I, Cristofanilli M, et al. (2018). Phase I study of alpelisib (BYL-719) and trastuzumab emtansine (T-DM1) in HER2-positive metastatic breast cancer (MBC)after trastuzumab and taxane therapy. Breast Cancer Res Treat. (Among 17 patients with HER2+ metastatic breast cancer progressing despite trastuzumab and taxane therapy who were then treated with alpelisib and trastuzumab-emtansine, the objective response rate was 43% but side effects were frequent including aminotransferase elevations [76%, but none above 5 times ULN], hyperglycemia [53%], fatigue [53%], rash [47%], nausea [41%]; but both beneficial and adverse effects may have been due to trastuzumab-emtansine).
Juric D, Janku F, Rodón J, Burris HA, Mayer IA, Schuler M, Seggewiss-Bernhardt R, et al. (2019). Alpelisib plus fulvestrant in PIK3CA-altered and PIK3CA-wild-type estrogen receptor-positive advanced breast cancer: a phase 1b clinical trial. JAMA Oncol. (Among 87 women with progressive ER+, HER2- breast cancer treated with escalating doses of alpelisib [300, 350 or 400 mg once daily], the objective response rate was 29% in the PIK3CA altered group but 0% in those with wild type alleles, while adverse events were common and led to dose modification in 69%, usually from hyperglycemia or rash; AST elevations arose in 15 patients [17%] but were above 5 times ULN in only 2, both in the highest dose cohort).
Mayer IA, Prat A, Egle D, Blau S, Fidalgo JAP, Gnant M, Fasching PA, et al. (2019). A phase II randomized study of neoadjuvant letrozole plus alpelisib for hormone receptor-positive, human epidermal growth factor receptor 2-negative breast cancer (NEO-ORB). Clin Cancer Res. (Among 257 women with HR+, HER2- early breast cancer who were treated with neoadjuvant letrozole plus either alpelisib [300 mg] or placebo daily for 24 weeks, objective response rates were similar in the two groups regardless of PIK3CA mutation status [without 41% vs 45% and with 63% vs 61%], while adverse events were more frequent with alpelisib, including serious adverse events [12% vs 1%], discontinuations for adverse events [9% vs none] and ALT elevations [11% vs 2%] which were above 5 times ULN in 3% vs 1%).
André F, Ciruelos E, Rubovszky G, Campone M, Loibl S, Rugo HS, Iwata H, et al., SOLAR-1 Study Group. (2019). Alpelisib for PIK3CA-mutated, hormone receptor-positive advanced breast cancer. N Engl J Med. (Among 572 patients with advanced HR+, HER2- breast cancer treated with fulvestrant with either alpelisib or placebo, median progression free survival was 39.3 vs 31.4 months overall, but was 11.0 vs 5.7 months in those with PIK3-CA mutations; adverse events arose in 99.4% vs 68.6% and were considered severe in 63.8% vs 37.7%, with hyperglycemia in 64% vs 10% and rash in 36% vs 6%; no mention of rates of ALT elevations or hepatotoxicity).
Markham A. (2019). Alpelisib: First Global Approval. Drugs. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy and safety of alpelisib shortly after its approval in the US as therapy in combination with fulvestrant for postmenopausal women or men with HR+, HER2-, PIK3CA-mutated advanced or metastatic breast cancer; adverse events were frequent including elevations in ALT levels in 44% vs 34% of controls treated with fulvestrant alone).
Rugo HS, André F, Yamashita T, Cerda H, Toledano I, Stemmer SM, Jurado JC, et al. (2020). Time course and management of key adverse events during the randomized phase III SOLAR-1 study of PI3K inhibitor alpelisib plus fulvestrant in patients with HR-positive advanced breast cancer. Ann Oncol. (Among 571 patients with advanced breast cancer treated with fulvestrant combined with alpelisib or placebo, adverse events arose in 99% vs 92%, including hyperglycemia [64% vs 10% usually within 2 weeks], diarrhea [58% vs 16%], decreased appetite [36% vs 11%] rash [36% vs 11%, usually within 1-2 weeks and decreased in incidence and severity by pretreating with antihistamines]; no discussion of ALT elevations or hepatotoxicity).
Wang DG, Barrios DM, Blinder VS, Bromberg JF, Drullinsky PR, Funt SA, Jhaveri KL, et al. (2020). Dermatologic adverse events related to the PI3Kα inhibitor alpelisib (BYL719) in patients with breast cancer. Breast Cancer Res Treat. (Among 102 women receiving alpelisib for breast cancer, 41 [40%] develop rash, mean 13 days after starting chemotherapy and lasting an average of 7 days, biopsy showing perivascular and interface lymphocytic dermatitis, with minimal increase in eosinophil counts and in ALT levels usually responding to antihistamines and local corticosteroid therapy, among 16 who interrupted therapy, 12 restarted alpelisib, and none re-developed rash).
André F, Ciruelos EM, Juric D, Loibl S, Campone M, Mayer IA, Rubovszky G, et al. (2021). Alpelisib plus fulvestrant for PIK3CA-mutated, hormone receptor-positive, human epidermal growth factor receptor-2-negative advanced breast cancer: final overall survival results from SOLAR-1. Ann Oncol. (Among 572 patients with PIK3CA-mutated, HR+, HER2- breast cancer, treatment with alpelisib and fulvestrant resulted in a median overall survival of 39.2 months vs 31.4 months in those receiving fulvestrant alone).
Narayan P, Prowell TM, Gao JJ, Fernandes LL, Li E, Jiang X, Qiu J, et al. (2021). FDA approval summary: alpelisib plus fulvestrant for patients with HR-positive, HER2-negative, PIK3CA-mutated, advanced or metastatic breast cancer. Clin Cancer Res. (Review of the chemical, pharmacological, toxicologic, clinical and safety data that supported the FDA approval of alpelisib with fulvestrant as therapy of advanced or metastatic PIK3Ca mutant breast cancer; safety data was based on 571 trial participants, among whom dose discontinuations for adverse reactions were done in 25% on alpelisib and fulvestrant vs 4.5% on fulvestrant alone; mentions that ALT elevations arose in 44% of alpelisib treated subjects).
Majeed U, Puiu T, Sluzevich J, Reynolds G, Acampora M, Moreno-Aspitia A, Bodiford KJ, et al. (2021). Case report: alpelisib-induced drug reaction with eosinophilia and systemic symptoms: a rare manifestation of a common side effect. Front Oncol. (52 year old woman with metastatic breast cancer developed rash 12 days after starting alpelisib, fulvestrant and cetirizine with periorbital edema, elevated white count, increase in eosinophils [1,310], decrease in platelets [72,000], and mild increase in liver tests [ALT 46 U/L, AST 74 U/L, bilirubin 1.7 mg/dL] [RegiSCAR score=8], responding rapidly to prednisone and not relapsing but having normal blood counts and liver tests 12 weeks after withdrawal).
Handy C, Wesolowski R, Gillespie M, Lause M, Sardesai S, Williams N, Grimm M, et al. (2021). Tumor lysis syndrome in a patient with metastatic breast cancer treated with alpelisib. Breast Cancer (Auckl). (66 year old woman with PIK3 mutated breast cancer developed altered mental state 12 days after starting alpelisib and fulvestrant with hallucinations, asterixis, creatine 15 mg/dL, uric acid 16.2 mg/dL, high potassium and high phosphate levels which responded to fluid and electrolyte replacement, allopurinol and rasburicase, laboratory values returning to normal in the next week; she later tolerated restarting alpelisib and fulvestrant).

## OTHER REFERENCE LINKS

1 Recent References on Alpelisib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Alpelisib/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Alpelisib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Alpelisib)